# Elements Needed In Reporting Cases Of Drug-Induced Liver Injury

Diagnosis of drug-induced liver disease relies upon knowing the time to onset and recovery, pattern of injury, exclusion of other causes of liver disease, and whether there was a recurrence of injury with re-exposure. These features are the basis for recommending that specific data elements are necessary when cases of drug-induced liver injury are reported to a Federal Agency (such as the Food and Drug Administration through MedWatch), to the pharmaceutical manufacturer, and in preparing a manuscript for publication of a case report or case series. The data elements should include all the information needed for making a diagnosis and to assess causality in suspected drug-induced liver injury. Without these pieces of information, it may simply be impossible to say whether or not drug-induced liver disease is the cause of the liver injury. In assessing and describing cases of drug-induced liver disease, these elements should be considered necessary:

- Name of the medication
- Dose and regimen of its administration
- Date that the medication was started
- Date that the medication was stopped (or duration of therapy)
- Date of first onset of symptoms of liver injury or blood test abnormalities (or time to onset)
- Sequence of events after onset including symptoms, interventions and serial laboratory tests (including ALT or AST or both, alkaline phosphatase, direct and total bilirubin, albumin and prothrombin time)
- IgM Anti-HAV to exclude hepatitis A
- HBsAg or IgM anti-HBc or both, to exclude hepatitis B
- Anti-HCV or HCV RNA or both to exclude hepatitis C
- Antinuclear antibody and globulin level to exclude autoimmune hepatitis
- Ultrasound of the liver and biliary system to exclude fatty liver disease and biliary obstruction
- Previous history of liver disease
- Risk factors for other forms of acute liver disease such as exposure to viral hepatitis, alcohol use, recent weight gain, and acute heart failure or severe hypotension

Other helpful pieces of information, that are not always available or necessary include:

- Previous history of exposure to the medication
- Previous history of drug-induced liver disease and drug allergies
- Previous liver test results before (or early during the course of) the administration of the medication
- Evidence of biochemical recovery after discontinuation of the implicated drug
- Liver biopsy histology

Full assessment of the likelihood of drug-induced liver disease may require further time and follow up, largely to demonstrate that the liver disease resolves or improves after withdrawal of the medication and another diagnosis does not become clear (such as autoimmune hepatitis marked by persistence of disease or a relapsing course despite stopping the drug, or acute hepatitis C marked by absence of detectable levels of anti-HCV at the onset). This is appropriate because proper management of patients with drug-induced liver disease calls for adequate follow up and documentation that the liver disease has resolved.

Drug-induced liver disease is usually acute and almost always self-limited. While medications can cause severe acute injury and death from liver failure, they rarely cause liver disease that persists despite discontinuation of the medication. There are instances, however, when chronic liver disease appears to arise as a result of a finite course of a medication.